# Famciclovir

## OVERVIEW

### Introduction

Famciclovir is a nucleoside analogue and antiviral agent used in therapy of herpes zoster and simplex virus infections. Famciclovir is associated with a low rate of mild-to-moderate serum ALT elevations during therapy, but has not been associated with instances of clinically apparent liver injury.

### Background

Famciclovir (fam sye' kloe vir) is an acyclic purine nucleoside analogue with antiviral activity against many herpes viruses, including herpes simplex 1 and 2, cytomegalovirus, Ebstein-Barr virus and varicella-zoster. Famciclovir is a prodrug of penciclovir which is the active component. After absorption, famciclovir is converted in the liver to penciclovir which is phosphorylated intracellularly by viral kinases; the resultant triphosphate competes with guanosine for incorporation into viral DNA, blocking viral DNA polymerase activity. Famciclovir is indicated for therapy of varicella zoster and for mucocutaneous or genital herpes simplex infections, both type 1 and 2. Famciclovir was approved for use in the United States in 1994 and is widely used in treatment of herpes zoster and prophylaxis of genital and mucocutaneous herpes simplex infection. Famciclovir is available as tablets of 125, 250 and 500 mg, generically and under the brand name of Famvir. The recommended dose of famciclovir and duration of therapy varies by indication. The typical recommended oral dose for herpes zoster in adults is 500 three times daily for 7 days; a lower daily dose is recommended for prophylaxis. Side effects are uncommon but can include headache, dizziness, and gastrointestinal upset.

### Hepatotoxicity

Famciclovir has been associated with a low rate of serum aminotransferase elevations during oral therapy. In pooled analyses of patients on long term suppressive therapy, 3.2% of famciclovir vs 1.5% of placebo recipients had ALT elevations above twice normal. The elevations were transient and asymptomatic and resolved even without dose modification. Since approval, cases of cholestatic jaundice have been reported to the sponsor, but there have been no published cases. Thus, clinically apparent liver disease due to famciclovir must be rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

After absorption, famciclovir is converted to penciclovir by the liver, which is metabolized intracellularly in viral infected cells. Hepatic metabolism of penciclovir is minimal and it is excreted largely unchanged by the kidneys, perhaps accounting for the absence or rarity of hepatic injury.

Drug Class: Antiviral Agents

Other Antiviral Agents for Herpes Virus Infections: Acyclovir, Cidofovir, Foscarnet, Ganciclovir, Letermovir, Valacyclovir, Valganciclovir

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Famciclovir – Famvir®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Famciclovir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Famciclovir | 104227-87-4 | C14-H19-N5-O4 | Famciclovir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 29 January 2018

Núñez M. Drugs used for herpes simplex and varicella-zoster viruses. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 512-3. (Review of hepatotoxicity of antiviral agents; famciclovir has been linked to ALT elevations in 3.2% of patients).
Acosta EP, Flexner C. Antiviral agents (nonretroviral). In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1593-1622. (Textbook of pharmacology and therapeutics).
Simpson D, Lyseng-Williamson KA. Famciclovir: a review of its use in herpes zoster and genital and orolabial herpes. Drugs 2006; 66: 2397-416. (Review of famciclovir, oral prodrug of penciclovir, used in herpes zoster and simplex virus infections for a limited period as therapy and extended use for suppression; in suppression studies, ALT elevations above twice ULN occurred in 3.2% of famciclovir vs 1.5% of placebo recipients; AST elevations in 2.3% of famciclovir vs 1.2% of placebo recipients; no hepatic serious adverse events were reported). 17181386
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antiviral agents including one due to valacyclovir, but none to famciclovir). 18955056
Mubareka S, Leung V, Aoki FY, Vinh DC. Famciclovir: a focus on efficacy and safety. Expert Opin Drug Saf 2010; 9: 643-58. (Review of the safety and efficacy of famciclovir mentions that serum ALT elevations can occur during therapy, but are usually mild and transient, and rates of abnormalities are similar in frequency to that with placebo or comparator arms). 20429777
Gopal MG, Shannoma, Kumar BCS, Ramesh M R, Nandini AS, Manjunath NC. A comparative study to evaluate the efficacy and safety of acyclovir and famciclovir in the management of herpes zoster. J Clin Diagn Res 2013; 7: 2904-7. (Controlled trial of 7 day course of oral acyclovir vs famciclovir in 100 patients with herpes zoster found similar efficacy and no differences in laboratory test results between the two groups, and no serious adverse events). 24551671
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to famciclovir). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Famciclovir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Famciclovir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Famciclovir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Famciclovir)